# Bile Acid Resins or Sequestrants

## OVERVIEW

The bile acid resins or sequestrants are the oldest and safest lipid lowering agents, but are less potent than other classes now available and are not always well tolerated. The bile acid sequestrants are highly positively charged molecules that bind to the negatively charged bile acids in the intestine, inhibiting their lipid solubilizing activity and thus blocking cholesterol absorption. They also inhibit the reabsorption of bile acids (which is typically 95%) and thus cause a contraction of the bile acid pool which leads to increased bile acid synthesis that competes with cholesterol synthesis in the liver, which also contributes to the lowering of serum cholesterol levels. Three bile acid sequestrants are available in the United States (common brand name and year of approval): cholestyramine (Questran, 1973), colesevelam (Welchol, 2000) and colestipol (Colestid, 1977). These agents are also used for therapy of pruritus for their activity in lowering the “pruritogens” that accumulate in cholestatic forms of liver disease. The bile acid resins are not absorbed and thus have not been linked to clinically apparent drug induced liver injury. They have the potential to bind to vitamins, hormones or medications in the intestine and result in subtherapeutic serum levels.

The bile acid resins have not been associated with clinically apparent acute liver injury, which is probably because of their lack of absorption. For unexplained reasons, however, therapy with these agents is associated with a low rate of mild (1 to 3 fold) serum aminotransferase and alkaline phosphatase elevations which are self-limited and not associated with symptoms or jaundice and resolve rapidly with stopping therapy.

Drug Class: Antilipemic Agents

Drugs in the Subclass, Bile Acid Resins/Sequestrants: Cholestyramine, Colesevelam, Colestipol

## ANNOTATED BIBLIOGRAPHY

References updated: 28 September 2017

Zimmerman HJ. Drugs used in the treatment of hypercholesterolemia and hyperlipidemia. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 660-2. (Expert review of hepatotoxicity published in 1999; cholestyramine has been mentioned as a cause of serum aminotransferase elevations, but “This is a curious phenomenon for a nonabsorbed drug”).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. Lipid regulating agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 526-7. (Review of hepatotoxicity of lipid lowering agents; the bile acid resins are not discussed).
Bersot TP. Drug therapy for hypercholesterolemia and dyslipidemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 877-908. (Textbook of pharmacology and therapeutics).
The Lipid Research Clinics Coronary Primary Prevention Trial results. I. Reduction in incidence of coronary heart disease. JAMA 1984; 251: 351-64. (Landmark trial of cholesterol lowering using cholestyramine for primary prevention of symptomatic coronary artery disease; patients on cholestyramine had higher serum AST levels that those on placebo during the first year of therapy; no hepatic serious adverse events or episodes of acute liver injury). 6361299
Di Padova C, Tritapepe R, Rovagnati P, Rossetti S. Double-blind placebo-controlled clinical trial of microporous cholestyramine in the treatment of intra- and extra-hepatic cholestasis: relationship between itching and serum bile acids. Methods Find Exp Clin Pharmacol 1984; 6: 773-6. (Placebo controlled trial of cholestyramine [3 g three times daily] in 10 patients with cholestasis; itching and bile acids were reduced, but no mention of serum enzymes or bilirubin levels). 6397677
The Lovastatin Study Group III. A multicenter comparison of lovastatin and cholestyramine therapy for severe primary hypercholesterolemia. JAMA 1988; 260: 359-66. (Controlled trial of lovastatin [20 or 40 mg/day] vs cholestyramine [16 g/day] for 12 weeks in 264 patients with hypercholesterolemia; mean ALT levels increased in cholestyramine treated patients and ALT levels >2 times normal occurred in 9% of cholestyramine vs 1% of lovastatin treated patients). 2898027
LaRosa J. Review of clinical studies of bile acid sequestrants for lowering plasma lipid levels. Cardiology 1989; 76 Suppl 1: 55-61. (Review of efficacy and safety of bile acid sequestrants; no mention of hepatotoxicity or serum enzyme elevations). 2653624
Stein E, Kreisberg R, Miller V, Mantell G, Washington L, Shapiro DR. Effects of simvastatin and cholestyramine in familial and nonfamilial hypercholesterolemia. Multicenter Group I. Arch Intern Med 1990; 150: 341-5. (Controlled trial of simvastatin [20 or 40 mg] vs cholestyramine [4-12 g/day] in 251 patients with hypercholesterolemia; “simvastatin was better tolerated”, week 12 ALT levels were >1.5 times ULN in 7.1% of cholestyramine treated vs 2.4% and 8.6% of simvastatin treated; Alk P elevated in 13% vs none on simvastatin). 2405804
Pravastatin Multicenter Study Group II. Comparative efficacy and safety of pravastatin and cholestyramine alone and combined in patients with hypercholesterolemia. Arch Intern Med 1993; 153: 1321-9. (Controlled trial of pravastatin vs cholestyramine vs both in 311 patients with hyperlipidemia treated for 8 weeks found that ALT elevations occurred in 21% of patients receiving cholestyramine alone and average ALT levels rose by 25%). 8507122
Ito MK, Shabetai R. Pravastatin alone and in combination with low-dose cholestyramine in patients with primary hypercholesterolemia and coronary artery disease. Am J Cardiol 1997; 80: 799-802. (Controlled trial of pravastatin alone vs combination with cholestyramine [10 g/day] for 18 weeks in 59 patients with hypercholesterolemia; there was a 44% increase in mean ALT levels in the combination group vs 8% increase in the pravastatin only group). 9315597
Davidson MH, Dillon MA, Gordon B, Jones P, Samuels J, Weiss S, Isaacsohn J, et al. Colesevelam hydrochloride (cholestagel): a new, potent bile acid sequestrant associated with a low incidence of gastrointestinal side effects. Arch Intern Med 1999; 159: 1893-900. (Controlled trial of colesevelam [4 dosages] vs placebo for 6 weeks in 149 patients with hypercholesterolemia; fatigue, flatulence, constipation and dyspepsia were most common adverse events; mean ALT and Alk P increased in some dosage groups, but there were no clinically significant changes, jaundice or symptoms). 10493319
Sirmans SM, Beck JK, Banh HL, Freeman DA. Colestipol-induced hepatotoxicity. Pharmacotherapy 2001; 21: 513-6. (65 year old man developed marked serum aminotransferase elevations [ALT 593 U/L] without symptoms or increases in Alk P [105 U/L] or bilirubin [0.6 mg/dL] 27 weeks after starting colestipol [10 g/day], resolving within a week of stopping; also on acetaminophen). 11310528
Hunninghake D, Insull W Jr, Toth P, Davidson D, Donovan JM, Burke SK. Coadministration of colesevelam hydrochloride with atorvastatin lowers LDL cholesterol additively. Atherosclerosis 2001; 158: 407-16. (Controlled trial of atorvastatin vs colesevelam vs the combination in 94 patients with hypercholesterolemia; mild increases in ALT and Alk P occurred in all three groups). 11583720
Aldridge MA, Ito MK. Colesevelam hydrochloride: a novel bile acid-binding resin. Ann Pharmacother 2001; 35: 898-907. (Review of pharmacology, efficacy and side effects of colesevelam; no serious adverse events have been reported; minor increases occur in ALT and Alk P, but average values remain in the normal range). 11485143
Knapp HH, Schrott H, Ma P, Knopp R, Chin B, Gaziano JM, Donovan JM, et al. Efficacy and safety of combination simvastatin and colesevelam in patients with primary hypercholesterolemia. Am J Med 2001; 110: 352-60. (Controlled trial of simvastatin vs colesevelam vs the combination vs placebo in 241 patients with hypercholesterolemia; “no clinically notable changes in chemistry or hematology values”). 11286949
Kondrackiene J, Beuers U, Kupcinskas L. Efficacy and safety of ursodeoxycholic acid versus cholestyramine in intrahepatic cholestasis of pregnancy. Gastroenterology 2005; 129: 894-901. (Controlled trial of ursodiol vs cholestyramine [8 mg/day] for 2 weeks in 84 women with intrahepatic cholestasis of pregnancy; serum ALT levels fell in ursodiol, but increased slightly in cholestyramine treated patients as did Alk P to a lesser extent). 16143129
Kawashiri MA, Higashikata T, Nohara A, Kobayashi J, Inazu A, Koizumi J, Mabuchi H. Efficacy of colestimide coadministered with atorvastatin in Japanese patients with heterozygous familial hypercholesterolemia (FH). Circ J 2005; 69: 515-20. (Open label study of atorvastatin followed by addition of colestimide in 15 patients with severe hypercholesterolemia; no changes in ALT or Alk P during therapy and no serious adverse events). 15849435
Bhardwah SS, Chalasani N. Lipid-lowering agents that cause drug-induced hepatotoxicity. Clin Liver Dis 2007; 11: 597-613. (Review of hepatotoxicity of lipid lowering agents: bile acid resins are mostly safe for the liver; mentions the case report of anicteric hepatitis due to colestipol [Sirmans 2000]). 17723922
Davidson MH. The use of colesevelam hydrochloride in the treatment 0f dyslipidemia: a review. Expert Opin Pharmacother 2007; 8: 2569-78. (Review of structure, pharmacology, mechanism of action, efficacy and safety of colesevelam; colesevelam has less side effects and fewer drug interactions than cholestyramine, no mention of changes in serum enzymes or hepatotoxicity). 17931091
Stein EA, Marais AD, Szamosi T, Raal FJ, Schurr D, Urbina EM, Hopkins PN, et al. Colesevelam hydrochloride: efficacy and safety in pediatric subjects with heterozygous familial hypercholesterolemia. J Pediatr 2010; 156: 231-6. (Controlled trial of colesevelam vs placebo in 194 children with hypercholesterolemia; side effects were mild and largely gastrointestinal; "there were no clinically meaningful changes in safety laboratory measurements"). 19879596
Kuiper EM, van Erpecum KJ, Beuers U, Hansen BE, Thio HB, de Man RA, Janssen HL, et al. The potent bile acid sequestrant colesevelam is not effective in cholestatic pruritus: results of a double-blind, randomized, placebo-controlled trial. Hepatology 2010; 52: 1334-40. (Controlled trial of colesevelam vs placebo for 3 weeks in 35 patients with pruritus due to chronic liver disease found a reduction in bile acid levels, but no change in pruritus; no mention of changes in serum enzymes). 20683930
Goldfine AB, Fonseca VA, Jones MR, Wang AC, Ford DM, Truitt KE. Long-term Safety and Tolerability of Colesevelam HCl in Subjects with Type 2 Diabetes. Horm Metab Res 2010; 42: 23-30. (A 52 week open label extension of trial of colesevelam in 509 patients with type 2 diabetes; 1 patient [0.2%] had ALT and 2 [0.4%] had AST elevations >3 times ULN, but these resolved without complications, with or without stopping colesevelam). 19862667
Le TA, Chen J, Changchien C, Peterson MR, Kono Y, Patton H, Cohen BL, et al.; San Diego Integrated NAFLD Research Consortium (SINC). Effect of colesevelam on liver fat quantified by magnetic resonance in nonalcoholic steatohepatitis: a randomized controlled trial. Hepatology 2012; 56: 922-32. (Controlled trial of 24 weeks of colesevelam vs placebo in 50 patients with nonalcoholic steatohepatitis found that colesevelam therapy was associated with a small increase in ALT [22.5 U/L], Alk P [8 U/L] and hepatic fat [14.2-17%], but decrease in serum cholesterol and no change in weight). 22431131
Singhal R, Harrill AH, Menguy-Vacheron F, Jayyosi Z, Benzerdjeb H, Watkins PB. Benign elevations in serum aminotransferases and biomarkers of hepatotoxicity in healthy volunteers treated with cholestyramine. BMC Pharmacol Toxicol 2014;15:42. (Among 67 healthy adult volunteers given placebo followed by cholestyramine [8 g daily] for 11 days, serum ALT levels rose above 3 times ULN in 11 subjects, starting 3 days into treatment, peaking at 119-967 U/L [3.5 to 28 times ULN], occurring without symptoms, jaundice or bilirubin elevations, and resolving within 2 weeks of stopping). 25086653
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to a bile acid resin). 25754159